# Cirrhosis

Description. Cirrhosis is a rare complication of drug induced liver injury. Indeed, cirrhosis is not a primary phenotype but rather a potential outcome of several types of injury. Cirrhosis can be the result of (1) severe or protracted acute injury, (2) chronic injury due to fatty liver disease, (3) prolonged injury due to chronic hepatitis, or (4) vanishing bile duct syndrome. Patients who develop cirrhosis usually present with signs and symptoms of chronic liver disease and portal hypertension such as fatigue, weight loss, hepatosplenomegaly, ascites, varices and muscle wasting. Occasionally, cirrhosis is the initial manifestation of drug induced liver injury, but generally only with specific medications and long term use.

Latency to Onset. The time to onset of cirrhosis due to medications is typically long; at least 6 months after starting the medication and usually several years afterwards.

Symptoms. The onset of symptoms of cirrhosis is usually insidious with fatigue, weakness, and muscle wasting, sometimes with abdominal distention and ascites, peripheral edema or variceal hemorrhage. Patients may have pruritus and jaundice depending upon the severity of the cirrhosis. Patients may improve markedly with stopping therapy, but the improvement is slow and there may be a period of worsening signs and symptoms when the medication is first stopped.

Serum Enzyme Elevations. ALT and alkaline phosphatase levels are usually only mildly elevated and may be normal in patients with drug induced cirrhosis. Other laboratory abnormalities may be present such as low platelet count, decreased serum albumin, mild bilirubin elevations and prolongation of the prothrombin time. In severe instances, serum ammonia may be elevated and hepatic encephalopathy present.

A sensitive marker of the development of progressive fibrosis and cirrhosis is the platelet count, which typically begins to decrease (while still in the "normal range") once bridging fibrosis is present and often falls below the lower limit of the normal range with cirrhosis. In addition, patients with cirrhosis often develop a rise in the ratio of the AST to ALT, the AST being a more reliable and durable marker for the degree of necroinflammatory activity in patients with cirrhosis. Indeed, the AST to platelet count ratio index (APRI) can be used as a convenient surrogate marker for advanced fibrosis and cirrhosis, the normal ratio being less than 0.5 and values above 1.0 being suggestive and above 1.5 strongly indicative of cirrhosis. The ratio is calculated as the AST expressed as a multiple of the upper limit of normal (AST/ULN) divided by the platelet count expressed as platelets/μL divided by 100,000:

APRI = (AST/ULN) / (Platelet count/100,000)

The APRI is unreliable during acute flares of disease and in patients with other causes for elevations in AST or decreases in platelet count. Serial measurements of APRI are likely to be more helpful than a single static measurement.

Drugs. The drugs that have been linked to causing cirrhosis most commonly are amiodarone, methotrexate, vitamin A and valproic acid. However, any agent that can cause acute liver failure may lead ultimately to posthepatic cirrhosis. In addition, agents that induce or exacerbate nonalcoholic fatty liver injury can cause cirrhosis if given in the face of chronic injury (tamoxifen). Similarly, drugs that induced a self-sustaining autoimmune hepatitis (fibrates, statins, alpha and beta interferon, tumor necrosis factor antagonists) may lead to cirrhosis. However, the most striking forms of cirrhosis from drug induced liver disease are those associated with vanishing bile duct syndrome (VBDS). VBDS usually arises after severe, acute cholestatic injury and can progress relentlessly despite prompt discontinuation of the medication and attempts at treatment with ursodiol and immunosuppressive agents. VBDS has been associated with multiple drugs, but most commonly with nonsteroidal antiinflammatory agents, sulfonamides, macrolide and fluoroquinolone antibiotics, the penicillins, amoxicillin/clavulanate, tricyclic antidepressants, antifungal agents and aromatic anticonvulsants. All forms of drug induced cirrhosis are rare and in large databases on liver transplantation, cirrhosis attributed to medications accounts for less than 1% of transplants.

Criteria for Definition. Diagnosis requires documentation of the presence of cirrhosis, usually by liver biopsy, but the diagnosis can be assumed if one or more of the following are present in the absence of acute liver failure:

1 Varices
2 Ascites
3 Hepatic encephalopathy
4 Radiological evidence of cirrhosis (nodular liver or enlargement of portal vein and splenomegaly)
5 Combination of low platelet count with persistent decrease in serum albumin or elevation in prothrombin time or bilirubin (above normal).

Other causes of cirrhosis should be excluded before the medication is considered the cause: the major ones being alcoholic liver disease, hepatitis B, C and D, nonalcoholic steatohepatitis, autoimmune hepatitis, primary biliary cirrhosis and sclerosing cholangitis. There remain cases of cirrhosis, however, that are cryptogenic and these are occasionally attributed to a medication. Once a drug is implicated, the major differential diagnosis is nodular regenerative hyperplasia (NRH), which can present clinically in a fashion very similar to cirrhosis. Without liver histology, NRH cannot be completely excluded, but that diagnosis is usually associated with other agents, such as thioguanine, azathioprine, mercaptopurine and oxaliplatin. Management is similar whether cirrhosis or NRH are present.

Management and Outcome. The most important element in management of drug induced cirrhosis is to recognize the association with a medication and stop it promptly. Thus, medication use should be scrutinized in any patient with a new diagnosis of cirrhosis particularly if it appears to be cryptogenic. Any such patient who is taking methotrexate, amiodarone, valproic acid, vitamin A or tamoxifen, should have those medications discontinued unless another etiology is clearly present and likely to be causing the injury. Patients with drug induced cirrhosis often improve once the medication is stopped and may have a lasting remission in symptoms and signs.

## REPRESENTATIVE CASES

### Case 1. Cirrhosis and end stage liver disease from long term therapy with amiodarone.(1)

A 62 year old man with chronic heart disease and a history of ventricular arrhythmias had been treated with amiodarone for almost 9 years when he presented with progressive weakness, abdominal discomfort and jaundice. He had had several episodes of raised serum aminotransferase levels while on long term amiodarone, but had never been jaundiced. He had no history of or risk factors for viral hepatitis and did not drink alcohol. His weight was normal with a body mass index of 23. He had multiple serious medication problems including coronary artery disease, hypertension, congestive heart failure, emphysema, pulmonary hypertension, hypercholesterolemia, mild renal insufficiency, migraine headaches, cholelithiasis and ulcerative colitis for which he received multiple medications listed below. The dose of amiodarone had varied from 150 to 1000 mg daily, but averaged 400 mg daily for the previous several years. On presentation, his total serum bilirubin was 3.0 with direct 2.0 mg/dL, ALT 781 U/L, AST 734 U/L and alkaline phosphatase 119 U/L. The prothrombin time was initially normal but serum albumin was low at 2.9 g/dL. Tests for hepatitis A, B and C were negative; he had a high titer of antinuclear antibody (1:640) but no mitochondrial antibody. Ultrasound showed hepatosplenomegaly and a small amount of ascites. A liver biopsy showed micronodular cirrhosis with ballooning degeneration of hepatocytes and Mallory bodies, but little steatosis. Amiodarone was stopped and his serum aminotransferase levels fell rapidly, but he continued to deteriorate over the next month with bilirubin rising to 7.6 mg/dL, albumin falling to 2.2 g/dL and prothrombin time rising to 23.3 seconds. He developed progressive obtundation and died approximately 8 weeks after stopping amiodarone.

#### Key Points

Medication: | Amiodarone (averaging 400 mg daily)
Pattern: | Hepatocellular (R=13.1)
Severity: | 5+ (liver failure and death within 6 months of diagnosis)
Latency: | 9 years
Recovery: | Died of progressive hepatic insufficiency
Other medications: | Carvedilol, enalopril, spironolactone, pravastatin, esomeprazole, azathioprine, mesalamine, temazepam, iron, epoetin, thiamine, and multivitamins

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | 49 | 80 | 0.5
1 year | | 67 | 114 | 0.6
5 years | | 40 | 80 | 1.0
6 years | | 48 | 96 | 1.2
7 years | | 123 | 111 | 0.8
8 years | | 42 | 89 | 1.3
8.5 years | 0 | 781 | 119 | 3.0 | Albumin 2.9 g/dL
Amiodarone stopped
| 3 days | 477 | 111 | 2.8 | Liver biopsy
| 1 week | 281 | 110 | 2.1 | ANA 1:640, AMA negative
| 3 weeks | 100 | 167 | 5.6
| 4 weeks | 74 | 156 | 7.6 | Albumin 2.2 g/dL, protime 23.3 sec
| 8 weeks | Died of hepatic failure
Normal Values | | <42 | <115 | <1.2

#### Comment

The history and clinical presentation were typical of chronic liver disease and cirrhosis due to long term amiodarone therapy. Also typical was the complexity of the underlying illness and multitude of other medical problems and drug exposures. During therapy, the patient had mild elevations in serum aminotransferase levels with occasional periods of marked activity and mild jaundice, but these were self-limited and did not result in interruption of therapy. Indeed, a liver biopsy had been done at the time of a cholecystectomy after 6 years of amiodarone therapy that showed mild degrees of zone 3 (centrolobular) necrosis with minimal sinusoidal fibrosis, which was attributed to hypotension and congestive heart failure. At that point there was no evidence of cirrhosis, inflammation or fat. Two years later, he developed progressive weakness and jaundice and had marked elevations in ALT and AST. A liver biopsy showed changes that were typical of amiodarone hepatotoxicity: micronodular cirrhosis with ballooning degeneration of hepatocytes and Mallory bodies. Despite stopping amiodarone once the liver injury was identified, this patient suffered from progressive hepatic failure and died approximately 8 weeks later. Recovery from amiodarone hepatotoxicity is slow and patients such as this one may have a period of worsening after stopping therapy. While chronic alcoholism and obesity are mentioned as risk factors for developing amiodarone toxicity, many patients, such as in the case above, develop severe liver injury without either of these risk factors for fatty liver disease and cirrhosis.

### Case 2. Cirrhosis after long term therapy with methotrexate.(2)

A 51 year old man with active rheumatoid arthritis was treated with methotrexate at an initial dose of 7.5 mg weekly, increasing to 15 mg weekly with daily folic acid and low doses of prednisone (5 mg daily) for four years with only partial control of his arthritis. He was then enrolled in an open label trial of the combination of methotrexate and leflunomide (10 mg/day). He had significant improvement and continued on both drugs for a total of 3.5 years. During the first year of therapy, he had minor and transient serum ALT elevations, but none were more than 3 times the upper limit of normal (ULN) (Table). Six months into combination therapy, however, his platelet count began to fall, and it remained low despite a decrease in the dose of methotrexate to 5 mg weekly. After 3.5 years of combination therapy, an abdominal ultrasound showed mild hepatomegaly, splenomegaly with increased echogenicity of the liver suggestive of fatty infiltration. He denied alcohol use and any history or risk factors for liver disease. He had been treated with methotrexate for 7.5 years and received a cumulative dose of 4.5 grams. Tests for hepatitis A, B and C were negative as were routine autoantibody tests. Liver tests including serum aminotransferase levels, alkaline phosphatase, bilirubin and albumin were normal and prothrombin time was not increased. A percutaneous liver biopsy showed marked fibrosis, early cirrhosis, mild steatosis and nuclear variability without inflammation or obvious necrosis.

#### Key Points

Medication: | Methotrexate (5-15 mg/week) for 7.5 years (total dose 4.5 grams)
Pattern: | Undefined (no serum enzyme elevation)
Severity: | 4+ (cirrhosis)
Latency: | ~5 years
Recovery: | Not mentioned
Other medications: | Leflunomide (10 mg/day for 3 years), folic acid, prednisone (5 mg/day)

#### Laboratory Values

Years After Starting | ALT (U/L) | Alk P (U/L) | Platelets (per μL) | Other
4 | 38 | 101 | 181,000 | Leflunomide started
4.2 | 39 | 119 | 206,000
4.4 | 57 | 111 | 150,000
4.6 | 28 | 105 | 129,000
4.8 | 27 | 111 | 109,000
5.0 | 38 | 106 | 105,000 | Methotrexate dose reduced
5.5 | 37 | 117 | 98,000
6.0 | 32 | 107 | 103,000
6.5 | 28 | 101 | 96,000
7.0 | 73 | 109 | 92,000 | Bilirubin and albumin normal
7.5 | 21 | 115 | 148,000 | Liver biopsy
Normal Values | <44 | <111 | >160,000

#### Comment

This case demonstrates how significant hepatic fibrosis and portal hypertension can arise during methotrexate therapy without accompanying symptoms or significant elevations in serum aminotransferase levels. Also characteristic was the mild and nonprogressive nature of the cirrhosis despite continuation of methotrexate. A possible noninvasive marker for the development of significant fibrosis in this case was the decrease in platelet count, which fell from 181,000/μL at baseline to 105,000 μL one year later, a 47% decline and a "platelet slope" of -74,000/year. In analyses of serial platelet count determinations in patients who developed portal hypertension, a platelet slope of -9,000/year was found to be indicative of the development of portal hypertension and hepatic dysfunction. Whether leflunomide contributed to the toxicity of methotrexate is not clear, but the findings are compatible with the duration and total dose of methotrexate received. The patient did not have typical risk factors for developing methotrexate related fibrosis such as excessive alcohol use, underlying viral hepatitis, renal insufficiency or diabetes (no mention is made of body weight or presence of obesity). While this patient did not qualify for undergoing surveillance liver biopsies (according to the criteria of the American College of Rheumatology), noninvasive tests such as PIIIP, hepatic imaging or elastography would have been appropriate and would likely have suggested the presence of significant fibrosis much earlier.

### Case 3. Cholestatic hepatitis followed by vanishing bile duct syndrome and cirrhosis after short course of thiabendazole.(3)

A 46 year old woman with suspected trichinosis was treated with thiabendazole (25 mg/kg twice daily for 5 days) and prednisone (40 mg/day). Two weeks later she noted dryness of the eyes and mouth with low grade fever. Shortly thereafter she developed dark urine and pruritus. She had no history of liver disease or drug allergies and drank little alcohol. On admission, she had prominence of the parotid glands and right upper quadrant tenderness without enlargement of the liver or spleen. She was jaundiced but had no other signs of chronic liver disease. Laboratory values showed a total bilirubin of 16.4 mg/dL with a direct of 11.5 mg/dL (Table). Serum aminotransferase levels were 3 to 20 fold elevated and 5' nucleotidase was 5 times elevated. Tests for hepatitis A and B and routine autoantibodies were normal. Ultrasound and CT scans of the abdomen showed no abnormalities and endoscopic retrograde cholangiopancreatography revealed no evidence of biliary obstruction. A liver biopsy showed marked intrahepatic cholestasis and a relative paucity of bile ducts. A salivary gland biopsy showed sialadenitis with prominent destruction of acini and ductules. She remained deeply jaundiced, but reevaluation showed no evidence for other liver disease. Over the next 8 months her symptoms of dry mouth and eyes improved, but she continued to have pruritus and mild jaundice. Two and a half years after exposure to thiabendazole, she developed ascites and variceal bleeding. A repeat liver biopsy showed micronodular cirrhosis with little inflammation and no steatosis. She remained negative for antinuclear (ANA), antimitochondrial (AMA), and antimicrosomal antibodies. Shortly thereafter, she underwent liver transplantation; the explant again showed micronodular cirrhosis.

#### Key Points

Medication: | Thiabendazole (25 mg/kg twice daily for 5 days)
Pattern: | Cholestatic pattern (R=~0.8)
Severity: | 5+ (ultimately leading to cirrhosis and liver transplantation)
Latency: | 2 weeks
Recovery: | Incomplete
Other medications: | Prednisone 40 mg daily for short period

#### Laboratory Values

Time After Starting | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Normal | Normal | Normal | Trichinosis
3 weeks | 142 | N/A | 16.4 | Admission
6 weeks | | | 28.1 | Liver biopsy
10 weeks | 50 | 248 | 23.5 | AMA and ANA negative
1 year | 108 | 584 | 2.2 | Sicca syndrome resolved
2.5 years | 98 | 487 | 2.6 | Variceal hemorrhage
Normal Values | <40 | <98 | <1.2

#### Comment

This case is a dramatic example of vanishing bile duct syndrome arising after a 5 day course of a medication. Thiabendazole typically causes an acute cholestatic hepatitis, but in half of cases the cholestatic hepatitis has been preceded by sicca syndrome with dry eyes and dry mouth and parotid enlargement. The cholestatic hepatitis is often associated with damage to bile ducts and can result in a prolonged jaundice with persistence of liver test abnormalities for months or years. In its most severe form, this prolonged cholestasis is also marked by vanishing bile duct syndrome that can result in cirrhosis, portal hypertension and end stage liver disease. The condition resembles primary biliary cholangitis, which also can be associated with keratoconjunctivitis sicca. This striking syndrome, several cases of which have been reported after short courses of thiabendazole, has not been reported with the other anthelmintic benzimidazoles, mebendazole and albendazole.

## CITED REFERENCES

1 [DILIN Case: 102-0019].
2 Weinblatt ME, Dixon JA, Falchuk KR. Serious liver disease in a patient receiving methotrexate and leflunomide. Arthritis Rheum 2000; 43: 2609-11.11083289
3 Roy MA, Nugent FW, Aretz HT. Micronodular cirrhosis after thiabendazole. Dig Dis Sci 1989; 34: 938-41.2721325

## SELECTED REFERENCES

Nyfors A, Poulsen H. Liver biopsies from psoriatics related to methotrexate therapy. 2. Findings before and after methotrexate therapy in 88 patients. A blind study. Acta Pathol Microbiol Scand A 1976; 84: 262-70. (Among 88 patients with psoriasis undergoing liver biopsy before and after 2-72 months [175-4590 mg] of weekly doses of methotrexate, 6 [7%] developed cirrhosis and 5 [6%] fibrosis with little correlation with dose, alcohol history, AST elevations or pre-treatment liver histology). 1274591
Simon JB, Manley PN, Brien JF, Armstrong PW. Amiodarone hepatotoxicity simulating alcoholic liver disease. N Engl J Med 1984; 311: 167-72. (Early report of clinical and histological features of amiodarone hepatotoxicity in a 30 year old man treated with amiodarone [400 mg/day] for 6 months, injury persisting for over a year after stopping; liver biopsy showed extensive fibrosis but not frank cirrhosis). 6738602
Bach N, Schultz BL, Cohen LB, Squire A, Gordon R, Thung SN, Schaffner F. Amiodarone hepatotoxicity: progression from steatosis to cirrhosis. Mt Sinai J Med 1989; 56: 293-6. (75 year old woman developed fever and hepatomegaly after 7 months of amiodarone therapy [800 mg/day] [bilirubin not given, AST 140 U/L, Alk P 850 U/L]; despite reduction in dose, progression to cirrhosis occurred over next 20 months: initial biopsy showed micro- and macrovesicular fat and ballooning; later biopsy showed cirrhosis, moderate inflammation, granular cells and Mallory bodies but no steatosis). 2797021
Roy MA, Nugent FW, Aretz HT. Micronodular cirrhosis after thiabendazole. Dig Dis Sci 1989; 34: 938-41. (46 year old woman developed dry eyes and mouth 2 weeks after a 5 day course of thiabendazole for trichinosis followed by jaundice and pruritus 1 week later [bilirubin 16.4 mg/dL, ALT 487 U/L], liver biopsy showed intrahepatic cholestasis and paucity of bile ducts, with prolonged jaundice and pruritus and variceal hemorrhage 2.5 years later: Case 3). 2721325
Lewis JH, Mullick F, Ishak KG, Ranard RC, Ragsdale B, Perse RM, Rusnock EJ, et al. Histopathologic analysis of suspected amiodarone hepatotoxicity. Hum Pathol 1990; 21: 59-67. (Summary of 19 cases of amiodarone hepatotoxicity from files of Armed Forces Institute of Pathology and review of literature: mean age 62 years [range 8 to 83 years], mostly men, mean dose 400 mg/day [200-800], duration of therapy 0.5-3.6 years; patients usually present with mild or no jaundice, hepatomegaly, mild ALT elevations and AST:ALT ratio <1.0, histology showed micro- and macrovesicular fat, Mallory bodies, fibrosis, foam cells, ductular proliferation, lipogranulomas, and inflammation; 9 patients had cirrhosis). 2403975
Weinblatt ME, Dixon JA, Falchuk KR. Serious liver disease in a patient receiving methotrexate and leflunomide. Arthritis Rheum 2000; 43: 2609-11. (51 year old man with rheumatoid arthritis was treated with leflunomide and methotrexate and had several ALT elevations and decline in platelet count during first 1-2 years of therapy and, after 3.5 years [total dose 4.5 grams], a liver biopsy showed cirrhosis and mild steatosis without inflammation: Case 2). 11083289
Berends MA, Snoek J, de Jong EM, van de Kerkhof PC, van Oijen MG, van Krieken JH, Drenth JP. Liver injury in long-term methotrexate treatment in psoriasis is relatively infrequent. Aliment Pharmacol Ther 2006; 24: 805-11. (125 patients with psoriasis treated with methotrexate for average of 4.4 years underwent 278 liver biopsies; 71% did not change from baseline; 15% developed fibrosis including 2% with cirrhosis; poor correlation of fibrosis with ALT and AST elevations; over half had other risk factors for liver disease such as obesity, diabetes or alcohol use). 16918884
Llanos L, Moreu R, Peiró AM, Pascual S, Francés R, Such J, Horga JF, et al. Causality assessment of liver injury after chronic oral amiodarone intake. Pharmacoepidemiol Drug Saf 2009; 18: 291-300. (Analysis of 39 cases of amiodarone hepatotoxicity from literature; mean age 69 years, latency 2-3 years [ALT 188 U/L, Alk P 265 U/L], 19 [48%] had cirrhosis, 15 [38%] died; Bayesian analysis suggests that amiodarone is cause of ALT elevations in only 50% of cases: ALT >3 times ULN occurring in 1.7% of treated patients, 0.8% of controls). 19165760
Scientific Registry of Transplant Recipients. January 31, 2010. (Among 46,633 liver transplants done in the United States between 2000 and 2009 in the SRTR registry, 31 [<0.1%] had the primary diagnosis of methotrexate induced cirrhosis).